# Elacestrant

## OVERVIEW

### Introduction

Elacestrant is an estrogen receptor antagonist which is used for treatment of specific forms of refractory, advanced or metastatic breast cancer in postmenopausal women or adult men. Elacestrant has not been linked to elevations in serum aminotransferase levels during therapy or to cases of clinically apparent liver injury.

### Background

Elacestrant (el” a ses’ trant) is a small molecule, estrogen receptor (ER) degrader that is used to treat postmenopausal women or adult men with advanced or metastatic breast cancer that is positive for ER and negative for human epidermal growth factor 2 (HER2). Elacestrant was the first orally available estrogen receptor degrader, a previous similarly active drug was fulvestrant which requires intramuscular injections every 2 to 4 weeks. Elacestrant binds to the estrogen receptor alpha and leads to its degradation, making cells resistant to estrogen-stimulated cell proliferation. In registration trials, elacestrant improved progression-free survival in women with advanced or metastatic, ER-positive, and HER2-negative breast cancer after failure of conventional antiestrogen therapy. Post hoc analyses showed that the benefit from elacestrant was largely in women who harbored an ESR1 mutation and when it was approved for use in the United States in 2023, the formal indications were limited to women with cancers and this specific mutation who have had disease progression following endocrine therapy. Elacestrant is available in tablets of 86 and 345 mg under the brand name Orserdu. The recommended dose is 345 mg daily to be continued until disease progression or unacceptable toxicity occurs. The dose can be decreased for adverse events or for preexisting moderate degrees of hepatic dysfunction. Common side effects include musculoskeletal pain, nausea, vomiting, diarrhea, abdominal pain, headache, and hot flushes. Laboratory abnormalities during elacestrant therapy can include increases in cholesterol and triglyceride, creatinine, and aminotransferase levels and decreases in hemoglobin and sodium. Less common but potentially severe adverse events include severe dyslipidemia and embryo-fetal toxicity.

### Hepatotoxicity

In the major registration trial of elacestrant as therapy of breast cancer, serum ALT elevations arose in similar proportions of those on elacestrant as of the controls receiving “standard of care” (9% vs 10%) and were above 5 times the upper limit of normal in 2.1% vs 0.9% of controls. The elevations were transient and without symptoms or jaundice. No patient developed clinically apparent liver injury. Since its approval and more widespread use, there have been no published reports of hepatotoxicity attributed to elacestrant therapy.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which elacestrant might cause liver injury is not known. Elacestrant is a complex small molecule (a tetrahydronaphthalene) and is metabolized in the liver, predominantly by CYP 3A4. Elacestrant is susceptible to drug-drug interactions; moderate inhibitors of CYP 3A4 can cause increases in plasma levels to potentially toxic levels, and moderate inducers of CYP 3A4 can cause decreases in plasma levels to potentially subtherapeutic levels.

### Outcome and Management

There is no evidence that elacestrant therapy can cause severe elevations in serum enzymes or lead to clinically apparent liver injury.

Drug Class: Antineoplastic Agents, Antiestrogens

Other Selective Estrogen Receptor Degraders: Fulvestrant

Other Selective Estrogen Receptor Modulators: Raloxifene, Tamoxifen, Toremifene

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Elacestrant – Orserdu®

DRUG CLASS

Antineoplastic Agents, Antiestrogens

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Elacestrant)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Elacestrant | 722533-56-4 | C30-H38-N2-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 25 February 2025

Abbreviations: ER, estrogen receptor; HER2, human epithelial growth factor 2.

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 699. (Expert review of hepatotoxicity published in 1999, before the availability of elacestrant and other estrogen receptor modulators and degraders).
Chitturi S, Farrell GC. Estrogen receptor antagonists. Adverse effects of hormones and hormone antagonists on the liver. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 610-2. (Review of hepatotoxicity of estrogens and antiestrogens discusses tamoxifen but not elacestrant or fulvestrant).
Isaacs C, Wellstein A, Riegel AT. Hormones and related agents in the therapy of cancer. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1237-1248. (Textbook of pharmacology and therapeutics).
FDA. 2023. Multi-Discipline Review. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2023/217639Orig1s000MultidisciplineR.pdf (FDA website with the product labels and integrated review of the data on efficacy and safety provided by the sponsor in support of approval of elacestrant as therapy of refractory and advanced, ER-positive breast cancer, mentions that ALT elevations were less frequent with elacestrant therapy than standard of care [17% vs 24%] including values greater than 5 times ULN [0.4% vs 1.3%], and there were no cases of clinically apparent liver injury).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: the DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, no cases were attributed to elacestrant). 25754159
Conlan MG, de Vries EFJ, Glaudemans A, Wang Y, Troy S. Pharmacokinetic and pharmacodynamic studies of elacestrant, a novel oral selective estrogen receptor degrader, in healthy post-menopausal women. Eur J Drug Metab Pharmacokinet. 2020; 45:675-689. (In phase 1 trials in 140 healthy, postmenopausal women, elacestrant demonstrated robust occupancy of estrogen receptors and acceptable tolerance, the most frequent adverse events being nausea, dyspepsia, vomiting, abdominal pain, esophageal pain, salivary hypersecretion, and diarrhea; and “there were no clinically significant changes in laboratory tests”). 32661909
Jager A, de Vries EGE, der Houven van Oordt CWM, Neven P, Venema CM, Glaudemans AWJM, et al. A phase 1b study evaluating the effect of elacestrant treatment on estrogen receptor availability and estradiol binding to the estrogen receptor in metastatic breast cancer lesions using ^18^F-FES PET/CT imaging. Breast Cancer Res. 2020; 22:97. (Among 16 patients with advanced ER-positive breast cancer treated with elacestrant [200 or 400 mg] once daily for 14 days followed by continuation at the higher dose, PET scanning at 14 days demonstrated a decrease in estrogen receptor activity, and continued treatment showed antitumor activity with acceptable toxicity; no mention of ALT elevations or hepatotoxicity). 32912274
Bardia A, Kaklamani V, Wilks S, Weise A, Richards D, Harb W, Osborne C, et al. Phase I study of elacestrant (RAD1901), a novel selective estrogen receptor degrader, in ER-positive, HER2-negative advanced breast cancer. J Clin Oncol. 2021;39: 1360-1370. (Among 57 postmenopausal, heavily pretreated women with advanced ER-positive, HER2-negative breast cancer treated with elacestrant [mostly with 400 mg daily], clinical responses occurred in 43% by 24 weeks, and adverse events were largely mild-to-moderate gastrointestinal complaints of nausea and vomiting, dyspepsia, abdominal pain, and fatigue, while ALT elevations arose in 18% and were above 5 times ULN in 4%, none were associated with jaundice or symptoms). 33513026
Bidard FC, Kaklamani VG, Neven P, Streich G, Montero AJ, Forget F, Mouret-Reynier MA, et al. Elacestrant (oral selective estrogen receptor degrader) versus standard endocrine therapy for estrogen receptor-positive, human epidermal growth factor receptor 2-negative advanced breast cancer: results from the randomized phase III EMERALD Trial. J Clin Oncol. 2022; 40:3246-3256. (Among 477 patients with advanced and refractory ER-positive, HER2-negative breast cancer treated with oral elacestrant [400 mg daily] vs standard of care, median progression-free survival at 1 year was 22% vs 8%, while adverse event rates were 92% vs 86%, the most frequent events being nausea [35% vs 19%], fatigue [19% vs 19%], vomiting [19% vs 8%], decreased appetite [15% vs 9%], and arthralgia [14% vs 16%]; ALT elevations arising in 9% vs 10% and were above 5 times ULN in 2% vs 0.9% ). 35584336
Hoy SM. Elacestrant: first approval. Drugs. 2023;83:555-561. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy, and toxicity of elacestrant shortly after its approval for use in breast cancer in the US, mentions the common gastrointestinal adverse events but does not mention ALT elevations or hepatotoxicity). 37060385
Shah M, Lingam H, Gao X, Gittleman H, Fiero MH, Krol D, Biel N, et al. US Food and Drug Administration approval summary: elacestrant for estrogen receptor-positive, human epidermal growth factor receptor 2-negative, ESR1-mutated advanced or metastatic breast cancer. J Clin Oncol. 2024;42:1193-1201. (Summary of the efficacy and safety data that supported the FDA decision to approve elacestrant as therapy of refractory, advanced or metastatic breast cancer, discusses the analysis of a safety cohort of 467 patients in whom there were no deaths, but discontinuations occurred in 6% of the treated vs 4.3% of standard of care controls; no mention of ALT elevations or hepatotoxicity). 38381994
Bardia A, Cortés J, Bidard FC, Neven P, Garcia-Sáenz J, Aftimos P, O'Shaughnessy J, et al. Elacestrant in ER+, HER2- metastatic breast cancer with ESR1-mutated tumors: subgroup analyses from the phase III EMERALD trial by prior duration of endocrine therapy plus CDK4/6 inhibitor and in clinical subgroups. Clin Cancer Res. 2024;30:4299-4309. (Among 477 patients with advanced and refractory ER-positive, HER2-negative breast cancer treated with oral elacestrant [400 mg daily] vs standard of care [Bardia 2022], subgroup analyses demonstrated improvements in progression-free survival was improved regardless of presence of ER mutations or previous therapies, and adverse event rates in these subgroups were similar, ALT elevations arising in 5% vs 12% [elacestrant vs standard of care] and were above 5 times ULN in 1.0% vs <1.0% ). 39087959

## OTHER REFERENCE LINKS

1. Recent References on Elacestrant: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Elacestrant/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Elacestrant: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Elacestrant)